# Ticlopidine

## OVERVIEW

### Introduction

Ticlopidine is an inhibitor of platelet aggregation that is used to decrease the risk of stroke in patients known to have atherosclerosis. Ticlopidine is associated with a low rate of serum enzyme elevations during treatment and has been linked to rare instances of idiosyncratic, clinically apparent acute liver injury.

### Background

Ticlopidine (tye kloe' pi deen) is an inhibitor of adenosine diphosphate (ADP)-induced platelet aggregation and is used to decrease the risk of recurrence of stroke in patients who have documented previous cerebrovascular thrombosis, and as adjunctive therapy with aspirin to reduce the risk of coronary stent thrombosis. Ticlopidine is a thienopyridine and prodrug that requires activation in the liver by the cytochrome P450 system. Activated platelets release ADP which binds to purinergic platelet receptors causing platelets to adhere to each other and aggregate. Ticlopidine acts by inhibiting the binding of ADP to platelet receptors and triggering of the intracellular pathways that lead to activation of the glycoprotein IIb/IIIa complex, which causes a change in the shape of platelets and their aggregation. The aggregation of platelets plays an important role in the growth of atheromatous plaques which can lead to coronary, cerebral and peripheral arterial occlusions. In large clinical trials, ticlopidine therapy has been shown to decrease the frequency of recurrence of fatal and nonfatal stroke. Ticlopidine was approved for use in the United States in 1991, but it is currently rarely used, largely because of the risks of serious side effects including agranulocytosis, thrombotic thrombocytopenic purpura and aplastic anemia and the availability of clopidogrel, which has a similar mechanism of action and efficacy, but a lower rate of adverse events. Current indications of ticlopidine include reduction of recurrence of stroke in patients with previous cerebrovascular thrombosis. In combination with aspirin, it is used for prevention of coronary stent occlusion. Ticlopidine is available in 250 mg tablets in several generic forms and formerly under the commercial name Ticlid. The usual dose is 250 mg twice daily taken with food. Side effects can include diarrhea, nausea, dyspepsia, rash, gastrointestinal upset, dizziness, anorexia and pruritus.

### Hepatotoxicity

Ticlopidine has been associated with serum enzyme elevations in approximately 4% of patients during therapy. These elevations are usually mild, asymptomatic and rarely require dose modification or stopping. Ticlopidine has also been associated with clinically apparent, acute liver injury. While these reactions are rare, more than 50 instances have been reported in the literature and some have been severe. The onset of symptoms is typically within 6 weeks (range 1 to 24 weeks) and marked by onset with fatigue, jaundice and itching. The usual pattern of liver enzyme elevations is cholestatic (~75%), but cases with mixed or hepatocellular enzyme elevations have also been described. Immunoallergic features such as fever, rash and eosinophilia can occur but are not common and, if present, are usually mild. Autoantibody formation is rare. Liver biopsy usually shows cholestatic hepatitis with mixed cellular infiltrates. Most cases are self-limited with recovery within 1 to 3 months, but isolated cases of prolonged jaundice or liver test abnormalities have been described, including at least one case of probable vanishing bile duct syndrome that eventually required liver transplantation. Ticlopidine therapy has also been associated with aplastic anemia and thrombotic thrombocytopenic purpura (TTP) that can be severe and lead to death; these patients may also have accompanying cholestatic liver injury.

### Mechanism of Injury

The mechanism of ticlopidine hepatotoxicity is not known, but is clearly idiosyncratic and may be due to the complex hepatic metabolism of the chlorophenyl-methyl-pyridine molecule. Immunoallergic features are usually not prominent, but hypersensitivity reactions have been described and cholestatic liver injury from ticlopidine has been linked to an extended HLA haplotype: A*33:03-B*44:03-Cw*14:03-DRB1*13:02-DQB1*1604 in Asian populations and to A*33:01 [which is homologous to a*33:03] in European populations.

### Outcome and Management

The severity of liver injury with ticlopidine ranges from minor serum enzyme elevations to clinically apparent cholestatic hepatitis. Most cases are self-limited and resolve completely. However, instances of prolonged cholestasis and vanishing bile duct syndrome due to ticlopidine have been reported. Ticlopidine is also associated with severe bone marrow toxicity, including aplastic anemia and agranulocytosis which can be accompanied by liver injury and which can be fatal. Interestingly, several patients have been described who suffered hepatotoxicity from ticlopidine, but who later tolerated clopidogrel without recurrence of liver injury. Nevertheless, switching to the related platelet aggregation inhibitor should be done with caution and prospective monitoring.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Clopidogrel, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar

## CASE REPORTS

### Case 1. Acute cholestatic hepatitis due to ticlopidine.(1)

A 66 year old man with diabetes, hyperlipidemia, aortic stenosis and coronary artery disease underwent cardiac catheterization and percutaneous placement of a stent in the left anterior descending artery. He was started on ticlopidine (250 mg twice daily) to help maintain stent patency. Approximately six weeks later he developed abdominal pain, nausea and diarrhea and discontinued ticlopidine. Over the next two weeks, however, he continued to feel poorly and developed dark urine and jaundice. He denied fever, chills, or skin rash. He had no history of liver disease and previously had normal liver tests. He denied alcohol abuse, previous drug allergies or risk factors for viral hepatitis. His other medications included fluvastatin (40 mg daily), bezafibrate (400 mg daily), metformin (850 mg twice daily) and atenolol (50 mg daily), which he had taken for years. On presentation, he was jaundiced but afebrile and without signs of chronic liver disease or cirrhosis. Laboratory tests showed a total bilirubin of 5.4 mg/dL, ALT 263 U/L, AST 114 U/L, alkaline phosphatase 99 U/L and GGT 17 U/L. The eosinophil count was 9%. Tests for acute hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound and computerized tomography were normal without evidence of biliary obstruction. Over the next several weeks, serum bilirubin and alkaline phosphatase levels continued to rise with a peak bilirubin of 19.3 mg/dL and alkaline phosphatase of 219 U/L. A liver biopsy showed features of severe cholestasis with mild steatosis and bile duct damage. He was treated with ursodiol and serum bilirubin levels began to fall. Ursodiol therapy was continued for 4 months and by six months after onset, all liver tests had returned to normal. His other medications had been continued without interruption.

#### Key Points

Medication: | Ticlopidine (250 mg twice daily for 4 weeks)
Pattern: | Hepatocellular evolving into cholestatic (R=6.4, later 0.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks to onset of symptoms, 8 weeks to jaundice
Recovery: | 4 months
Other medications: | Fluvastatin, bezafibrate, metformin, atenolol chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
8 weeks | 2 weeks | 263 | 99 | 5.4 | Admission
9 weeks | 3 weeks | 145 | 115 | 7.2
10 weeks | 4 weeks | 55 | 180 | 12.8
11 weeks | 5 weeks | 50 | 219 | 19.3 | Ursodiol started
12 weeks | 6 weeks | 85 | 205 | 16.9
13 weeks | 7 weeks | 86 | 200 | 13.5
16 weeks | 10 weeks | 65 | 185 | 3.0
18 weeks | 12 weeks | 45 | 145 | 1.2
5 months | 14 weeks | 25 | 120 | 0.8
6 months | 4 months | 20 | 95 | 0.4
Normal Values | | <40 | <115 | <1.2

* Some values estimated from figure.

#### Comment

While the pattern of serum enzyme elevations was hepatocellular at the time of presentation (R=6.5), the liver enzymes soon evolved to a distinctly cholestatic pattern as marked by a fall in serum aminotransferase and rise in alkaline phosphatase levels. Jaundice was profound and a liver biopsy confirmed the cholestatic nature of the injury. This case demonstrates the complexities of defining liver injury as cholestatic vs hepatocellular and demonstrates why there are discrepancies in the literature on the relative frequency of the two patterns associated with injury from a specific agent. The pattern of injury is said to be cholestatic in 75% to 80% of cases of ticlopidine hepatotoxicity. As is typical of cholestatic liver injury, recovery can be delayed and prolonged. In particular, serum alkaline phosphatase and GGT levels can remain elevated for months after clinical recovery. These abnormalities are usually benign and ultimately resolve, but may also represent some degree of bile duct damage and loss the long term implications of which are unknown.

### Case 2. Acute cholestatic hepatitis due to ticlopidine.(2)

A 72 year old man developed fatigue followed by jaundice 3 weeks after starting ticlopidine (100 mg three times daily) for carotid artery disease. He had no other symptoms and specifically denied, fever, chills, abdominal pain, rash, nausea or vomiting. He had no previous history of liver disease, alcohol abuse, drug allergies or risk factors for viral hepatitis. His other medications included loratadine (antihistamine) and timepidium bromide (antispasmodic), which he had been taking for two months. Laboratory tests showed a total serum bilirubin of 12.8 mg/dL (9.3 mg/dL direct), ALT 847 U/L, AST 393 U/L, alkaline phosphatase 487 U/L, and GGT 648 U/L (Table). Complete blood counts were normal without eosinophilia. Tests for acute hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound showed no abnormalities and endoscopic retrograde cholangiopancreatography showed no evidence of biliary obstruction. A liver biopsy showed focal hepatocellular necrosis and cholestasis which was interpreted as compatible with drug induced liver injury. Ticlopidine was stopped on initial presentation and there was an immediate although gradual improvement in liver tests.

#### Key Points

Medication: | Ticlopidine (300 mg daily)
Pattern: | Mixed (R=4.4)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks
Recovery: | 3 months
Other medications: | Loratadine, timepidium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
3 weeks | 0 | 847 | 487 | 12.8 | Ticlopidine stopped
4 weeks | 7 days | 529 | 420 | 13.9
5 weeks | 18 days | 266 | 415 | 8.6
7 weeks | 1 month | 90 | 296 | 3.4
11 weeks | 2 months | 48 | 204 | 1.2
13 weeks | 2.5 months | 38 | 200 | 0.9
Normal Values | | <40 | <100 | <1.2

* Estimated from figure.

#### Comment

Ticlopidine has been linked to more than 50 cases of clinically apparent, acute liver injury in the published literature. Most cases were reported from Europe, probably because it was introduced in many European countries in 1978, but was not commercially available in the United States until 1991. Most cases of ticlopidine hepatotoxicity are cholestatic, but mixed patterns of injury (as in this case) have been described. Ticlopidine is associated with several serious adverse events including aplastic anemia and thrombotic thrombocytopenic purpura and has been largely replaced by clopidogrel which appears to lead to bone marrow and hepatic injury much less commonly.

### Case 3. Acute cholestatic hepatitis due to ticlopidine.(3)

A 91 year old man was found to have marked elevations in serum aminotransferase levels at the time of a hospital admission for hip fracture 4 weeks after he started ticlopidine (250 mg twice daily) because of transient ischemic attacks. He had no symptoms of liver disease at the time and physical examination showed no evidence of jaundice. He had no history of liver disease, alcohol abuse, drug allergies or risk factors for viral hepatitis. His other medications included prednisone 5 mg every other day for rheumatoid arthritis and aspirin 325 mg daily for atrial fibrillation, both of which he had taken for several years. Laboratory tests showed a serum bilirubin of 0.6 mg/dL, ALT 293 U/L, AST 358 U/L and alkaline phosphatase 154 U/L. These values had been completely normal a month previously, just before he started ticlopidine (Table). Ticlopidine was discontinued and he underwent a successful open reduction of the fracture of the femur. Two weeks later he was transferred to another hospital and was found to be jaundiced on admission. He still had no symptoms of nausea, anorexia, abdominal pain or pruritus. Abdominal imaging showed no evidence of biliary obstruction or hepatic abnormality. With no further intervention, serum aminotransferase levels and bilirubin fell into the normal range within 9 weeks of the initial elevations.

#### Key Points

Medication: | Ticlopidine (250 mg twice daily)
Pattern: | Initially hepatocellular (R=6.1), subsequently cholestatic (R=0.6)
Severity: | 2+ (jaundice without symptoms)
Latency: | 4 weeks to enzyme elevations, 6 weeks to jaundice
Recovery: | 2 months
Other medications: | Aspirin, prednisone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | 20 | 69 | 1.5 | Ticlopidine started
4 weeks | 0 | 293 | 154 | 0.6 | Ticlopidine stopped
8 weeks | 4 days | 190 | 648 | 5.4 | Transfer to new hospital
9 weeks | 10 days | 96 | 475 | 5.8
10 weeks | 16 days | 87 | 550 | 3.6
| 18 days | 71 | 449 | 3.1
12 weeks | 5 weeks | 24 | 287 | 2.7
13 weeks | 6 weeks | .. | 217 | 2.0
14 weeks | 7 weeks | .. | 189 | 1.4
16 weeks | 9 weeks | .. | 127 | 1.2
Normal Values | | <40 | <130 | <1.2

#### Comment

Ticlopidine typically causes a cholestatic hepatitis with a time to onset of 2 to 12 weeks, but the timing of onset and enzyme pattern varies. Part of the variability, however, relates to the definitions of time of onset and cholestatic vs hepatocellular. In this instance, the time to first serum enzyme elevations was 4 weeks, but time to jaundice was 7 to 8 weeks. In addition, the definition of cholestatic relies upon the relative elevations of serum ALT and alkaline phosphatase levels which can change during the course of the injury. As shown in this case, the enzyme elevations are often hepatocellular at the onset of injury (before jaundice) and yet evolve into a cholestatic pattern once jaundice arises or at time of peak bilirubin elevation. This case was atypical in the absence of pruritus and clinical symptoms, but the coadministration of prednisone and the patient’s age may account for the paucity of clinical complaints.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ticlopidine – Generic, Ticlid®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ticlopidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ticlopidine | 55142-85-3 | C14-H14-Cl-N-S

## CITED REFERENCES

1 Skurnik YD, Tcherniak A, Edlan K, Sthoeger Z. (2003). Ticlopidine-induced cholestatic hepatitis. Ann Pharmacother.
2 Chen LK, Hsieh BH, Chen WC, Tsai ST, Hou MC. (2001). Ticlopidine-induced hepatitis. Zhonghua Yi Xue Za Zhi (Taipei).
3 Nurhussein MA. (1993). Ticlopidine-induced prolonged cholestasis. J Am Geriatr Soc.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999; ticlopidine is said to have been implicated in at least 32 cases of cholestatic and 2 of hepatocellular liver injury, usually with onset within 6 weeks of starting).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 520-40. (Review of hepatotoxicity of antiplatelet drugs including ticlopidine which has been linked to more than 30 cases of acute liver injury).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 849-76. (Textbook of pharmacology and therapeutics).
Biour M, Toussaint P, Duhamel G, Canuel C, Krulick M, Calmus Y. (1982). Therapie. (5 cases of severe side effects due to ticlopidine, one liver-related: 48 year old man developed jaundice and pruritus 3 months after starting ticlopidine [bilirubin 26.3 mg/dL, ALT 80 U/L, Alk P 1000 U/L], resolving over next 7 months).
Deschamps JP, Lassègue A, Ottignon Y, Vuitton D, Allemand H, Carayon P, Miguet JP. (1982). Gastroenterol Clin Biol. (2 cases: 45 year old woman developed rash followed by pruritus and jaundice 24 days after starting ticlopidine [bilirubin 5.8 mg/dL, ALT 405 U/L, Alk P 500 U/L], jaundice resolving 1 month and Alk P elevations 10 months after stopping; 82 year old woman developed jaundice 20 days after starting ticlopidine [bilirubin 12.9 mg/dL, ALT 180 U/L, Alk P 550 U/L], jaundice resolving in 3 and Alk P elevations 10 months after stopping).
Saint-Marc Girardin MF, Cordonnier C. (1982). Gastroenterol Clin Biol. (86 year old woman developed jaundice and agranulocytosis 4 weeks after starting ticlopidine [bilirubin 7.1 rising to 15.8 mg/dL, ALT 42 U/L, Alk P 180 U/L, white count 1000/µL], with progressive pancytopenia, sepsis and death 2 weeks after presentation).
Eugene C, Lefebvre JF, Gury B, Quevauvilliers J. (1983). Sem Hop. (71 year old woman developed jaundice within 10 days of starting ticlopidine [bilirubin 5.3 mg/dL, ALT 6 times ULN, Alk P 4 times ULN], resolving within 1 month of stopping).
Hass WK, Easton JD, Adams HP, Pryse-Phillips W, Molony BA, Anderson S, Kamm B. (1989). A randomized trial comparing ticlopidine hydrochloride with aspirin for the prevention of stroke in high-risk patients. Ticlopidine Aspirin Stroke Study Group. N Engl J Med. (Among 3069 patients with high risk from stoke treated with ticlopidine or aspirin for 2 to 6 years, side effects of ticlopidine included diarrhea [20.4% vs 9.8%], rash [11.9% vs 5.2%], and severe but reversible neutropenia [0.9% vs none] usually within first 3 months; no mention of liver injury or ALT elevations).
Gent M, Blakely JA, Easton JD, Ellis DJ, Hachinski VC, Harbison JW, Panak E, et al. (1989). The Canadian American Ticlopidine Study (CATS) in thromboembolic stroke. Lancet. (Among 1072 patients treated with ticlopidine or placebo after thromboembolic stroke, side effects included severe neutropenia [1% vs 0.1%], rash [15% vs 8%], diarrhea [22% vs 10%], and abnormal liver function [4.4% vs 1.5%] which was severe in 2 patients on ticlopidine).
Janzon L, Bergqvist D, Boberg J, Boberg M, Eriksson I, Lindgärde F, Persson G, et al. (1990). Prevention of myocardial infarction and stroke in patients with intermittent claudication; effects of ticlopidine. Results from STIMS, the Swedish Ticlopidine Multicentre Study. J Intern Med. (Among 687 patients with intermittent claudication treated with ticlopidine or placebo for up to 5 years, side effects included diarrhea [22% vs 9%], rash [3.5 vs 1.8%], cytopenia [1.8% vs none], and hepatic symptoms [1.7% vs 1.8%]).
Balsano F, Rizzon P, Violi F, Scrutinio D, Cimminiello C, Aguglia F, Pasotti C, et al. (1990). Antiplatelet treatment with ticlopidine in unstable angina. A controlled multicenter clinical trial. The Studio della Ticlopidina nell'Angina Instabile Group. Circulation. (Among 652 patients with unstable angina treated with ticlopidine or placebo for 6 months, side effects requiring discontinuation included diarrhea, nausea, abdominal pain and rash, but no mention of liver injury or ALT elevations).
Mammarella A, Paoletti V, Moroni C, Cassone R. (1991). Clin Ter. (67 year old man developed jaundice 2 weeks after starting ticlopidine [bilirubin 26.9 mg/dL, ALT 122 U/L, Alk P 1156 U/L], resolving within 3 months of stopping).
Miyahara K, Kasahara N, Kondo Y, Imai Y, Matuzaki F. (1991). Changes in plasma lipids and abnormal lipoproteins in a patient with drug-induced cholestatic hepatitis. Jpn J Med. (65 year old woman developed rash and abdominal pain 2 weeks after starting ticlopidine and jaundice 2 weeks later despite stopping therapy [bilirubin 22.3 mg/dL, ALT 395 U/L, GGT 3,326 U/L], with resolution in 2 months but persistence of GGT elevations [796 U/L 6 months later]).
Greany JJ, Hess DA, Mahoney CD. (1993). Ticlopidine-induced cholestatic jaundice. Clin Pharm. (78 year old woman developed jaundice 6 weeks after starting ticlopidine [bilirubin 6.3 mg/dL, ALT 550 U/L, Alk P 330 U/L], resolving with stopping drug but little follow up available).
Nurhussein MA. (1993). Ticlopidine-induced prolonged cholestasis. J Am Geriatr Soc. (92 year old man developed elevated enzymes [ALT 293 U/L, AST 358 U/L, Alk P 154 U/L] 4 weeks after starting ticlopidine and was found to be jaundiced with a cholestatic hepatitis 3-4 weeks later [bilirubin 5.4 mg/dL, ALT 96 U/L, Alk P 648 U/L], resolving within the next two months: Case 3).
Sondag D, Bader R, Claude P, Schreiber M. (1993). Ann Gastroenterol Hepatol (Paris). (60 year old man developed jaundice 6 weeks after starting ticlopidine [bilirubin not given, ALT 458 U/L, Alk P 252 U/L, GGT 920 U/L], resolving rapidly).
Weber E, Donckier J. (1994). Acta Clin Belg. (63 year old man developed jaundice 6 weeks after starting ticlopidine [bilirubin 4.3 mg/dL, ALT 156 U/L, Alk P 353 U/L], resolving within 1 month of stopping).
Yoder JD, Algozzine GJ, Hill GW. (1994). More ticlopidine-induced cholestatic jaundice. Am J Hosp Pharm. (Two cases; 69 year old woman developed jaundice and nausea 1 week after starting ticlopidine [bilirubin 2.0 mg/dL, ALT 183 U/L, Alk P 442 U/L], resolving rapidly once drug was stopped; 84 year old woman developed jaundice within 3 weeks of starting ticlopidine [bilirubin 8.5 mg/dL, ALT 217 U/L, Alk P 584 U/L], resolving within 2 months of stopping).
Grimm IS, Litynski JJ. (1994). Severe cholestasis associated with ticlopidine. Am J Gastroenterol. (92 year old man developed jaundice 3 months after starting ticlopidine [bilirubin 22.1 mg/dL, ALT 140 U/L, Alk P 577 U/L], resolving within 4 months of stopping).
Colvicchi F, Magnanimi S, Sebastiani F, Silvestri R, Magnanimi R. (1994). Ticlopidine-induced chronic cholestatic hepatitis: a case report. Curr Ther Res. (76 year old man developed jaundice and pruritus 40 days after starting ticlopidine [bilirubin 7.5 mg/dL, ALT 90 U/L, Alk P 910 U/L], symptoms resolving upon stopping, but liver tests still abnormal 1 year later [bilirubin 2.2 mg/dL, ALT 66 U/L, Alk P 760 U/L]).
Cassidy LJ, Schuster BG, Halparin LS. (1995). Probable ticlopidine-induced cholestatic hepatitis. Ann Pharmacother. (76 year old man developed jaundice 3 weeks after starting ticlopidine [bilirubin 18.0 mg/dL, AST 266 U/L, Alk P 580 U/L, GGT 769 U/L], resolving within 3 months of stopping).
Ruiz-Valverde P, Zafon C, Segarra A, Ribera R, Piera L. (1995). Ticlopidine-induced granulomatous hepatitis. Ann Pharmacother. (75 year old man developed fatigue 4 weeks after starting ticlopidine [bilirubin 0.7 mg/dL, ALT 50 U/L, Alk P 1526 U/L, GGT 886 U/L], resolving upon stopping).
Miras Parra FJ, Gómez Jiménez FJ, García Contreras T, Valverde Romera M. (1995). Rev Esp Enferm Dig. (70 year old woman developed jaundice approximately 4 months after starting ticlopidine [bilirubin 10.1 mg/dL, ALT 487 U/L, GGT 286 U/L], resolving within 1 month of stopping).
Naschitz JE, Khamessi R, Elias N, Yeshurun D. (1995). Ticlopidine-induced prolonged cholestasis. J Toxicol Clin Toxicol. (78 year old woman developed fatigue and pruritus 2 weeks after starting ticlopidine [bilirubin 1.7 mg/dL, ALT 285 U/L, Alk P 220 U/L, GGT 2085 U/L], resolving within 2 months of stopping).
López P, Castiella A, Bujanda L, Arenas JI. (1995). Rev Esp Enferm Dig. (74 year old man developed jaundice 3 months after starting ticlopidine [bilirubin 4.7 mg/dL, ALT 745 U/L, Alk P 499 U/L], resolving within 3 months of stopping).
Roy L, Plante M-A, Perreault H, Biron P. (1995). Cholestatic hepatitis: ticlopidine suspected. Therapie. (72 year old woman developed jaundice 3 weeks after starting ticlopidine [bilirubin 2.2 rising to 7.3 mg/dL, ALT 2661 U/L, Alk P 910 U/L], resolving within 6 weeks of stopping).
Pistone AM, Podesta F, Raviolo E, Testa D, Grosso B, Toselli P, Nyffeneger G. (1986). Recenti Prog Med. (54 year old woman developed jaundice 1 month after starting ticlopidine [bilirubin 12.6 mg/dL, ALT 112 U/L, Alk P 856 U/L], with slow and incomplete recovery after stopping).
Pascual S, Sarrión JV, Jarque I, Argüello L, Berenguer J. (1996). Gastroenterol Hepatol. (65 year old woman developed jaundice 3 months after starting ticlopidine [bilirubin 11 mg/dL, ALT 126 U/L, Alk P 830 U/L, GGT 2296 U/L], resolving within 3 months of stopping).
Klepser TB, Jogerst GJ. (1997). Ticlopidine-induced elevated liver enzymes. Pharmacotherapy. (82 year old woman developed fatigue 6 weeks after starting ticlopidine [bilirubin 0.7 mg/dL, ALT 69 U/L, Alk P 649 U/L, GGT 1385 U/L], symptoms resolving rapidly but liver test abnormalities requiring 6 months to resolve).
Díaz Fuenzalida A, Valdés Socín H, Laudano O, Avagnina A, Findor JA. (1997). Gastroenterol Hepatol. (56 year old man developed jaundice 3 months after starting ticlopidine [bilirubin 20.8 mg/dL, ALT 48 U/L, Alk P 1100 U/L], resolving within 4 months of stopping).
Yim HB, Lieu PK, Choo PW. (1997). Ticlopidine induced cholestatic jaundice. Singapore Med J. (65 year old woman developed jaundice 2 months after starting ticlopidine [bilirubin 6.9 mg/dL, ALT 251 U/L, Alk P 1158 U/L], with incomplete resolution 3 months later when she died of a stroke).
Guzzini F, Banfi L, Gomitoni A, Marchegiani C, Novati P, Mesina M, Frigerio B. (1997). Recenti Prog Med. (29 and 73 year old women developed jaundice 3 and 4 weeks after starting ticlopidine [bilirubin 3.1 and 7.4 mg/dL, ALT 244 and 101 U/L, Alk P 814 and 873 U/L], resolving within 3 months of stopping in one and after a year in the other).
Flamenbaum M, Zenut M, Castillo D, Costes-Charlet N, Kemeny JL, Lavarenne J, Cassan P. (1997). Therapie. (65 year old woman developed rash followed by jaundice one month after starting ticlopidine [bilirubin 3 times ULN, ALT 13 times ULN, Alk P 6 times ULN], resolving within 5 months).
Friedman ND, Sitlington R, Lodge RS. (1997). Thrombocytopenia and hepatitis complicating ticlopidine therapy. Aust N Z J Med. (72 year old man developed jaundice, pruritus and rash 1 month after starting ticlopidine [bilirubin 4.9 mg/dL, AST 42 U/L, Alk P 143 U/L, GGT 412 U/L], resolving within 3 months of stopping).
San Juan Portugal F, Jiménez Saez J, Naya Manchado J, Fuentes Solsona F. (1997). An Med Interna. (54 year old man developed jaundice 2 months after starting ticlopidine [bilirubin 4.5 mg/dL, ALT 295 U/L, Alk P 689 U/L], resolving within 2 months of stopping).
Sánchez-Bisonó JR, Gómez-Moli J, Escudero-Cantó M. (1997). Probable ticlopidine-induced severe aplastic anemia and cholestatic hepatitis. Haematologica. (67 year old man developed jaundice and pancytopenia 8 weeks after starting ticlopidine [bilirubin 18 mg/dL, ALT 24 U/L, Alk P 512 U/L], resolving within 3 weeks of stopping).
Artímez ML, Fernández E, Rodríguez M, González M, Rodrigo L. (1997). Rev Esp Enferm Dig. (Three patients, 86, 83 and 72 year olds, 2 men and 1 woman, developed jaundice 1-2 months after starting ticlopidine [bilirubin 3.2, 11.1 and 25.3 mg/dL, ALT 196, 363 and 225 U/L, Alk P 1033, 2130 and 1072 U/L], resolving 1-2 months after stopping).
Ceylan C, Kirimli O, Akarsu M, Undar B, Güneri S. (1998). Early ticlopidine-induced hepatic dysfunction, dermatitis and irreversible aplastic anemia after coronary artery stenting. Am J Hematol. (68 year old woman developed fever and rash 2 weeks after starting ticlopidine [bilirubin 3.7 mg/dL, ALT 423 U/L, Alk P 317 U/L], with aplastic anemia leading rapidly to sepsis and death).
Sossai P, Corte GD, Marenzi R. (1998). Liver injury with the use of ticlopidine. Ann Pharmacother. (51 year old man developed liver test abnormalities 2 weeks after starting ticlopidine [bilirubin 1.0 mg/dL, ALT 200 U/L, Alk P 632 U/L], which resolved within 3 weeks of stopping).
Martínez Pérez-Balsa A, De Arce A, Castiella A, López P, Ruibal M, Ruiz-Martínez J, López De Munain A, Martí Massó JF. (1998). Hepatotoxicity due to ticlopidine. Ann Pharmacother. (51 year old woman developed pruritus and skin rash 6 weeks after starting ticlopidine [bilirubin 0.5 mg/dL, ALT 575 U/L, Alk P 1069 U/L], resolving within 4 months of stopping; skin rash later diagnosed as eczema).
Iqbal M, Goenka P, Young MF, Thomas E, Borthwick TR. (1998). Ticlopidine-induced cholestatic hepatitis: report of three cases and review of the literature. Dig Dis Sci. (3 cases, all women, ages 74-84 years, onset after 2-4 weeks with jaundice [bilirubin 3.8- 32.4 mg/dL, ALT 119-353 U/L, Alk P 326-454 U/L, GGT 263-780 U/L], resolving in 6 to 12 weeks; review of 28 cases in literature).
Wegmann C, Müaier R, Dormann AJ, Huchzermeyer H. (1998). Dtsch Med Wochenschr. (52 year old man developed pruritus after 4 and jaundice after 6 weeks of ticlopidine [peak bilirubin 26.4 mg/dL, ALT 197 U/L, Alk P 420 U/L], with prolonged jaundice and resolution 10 weeks after stopping).
Grieco A, Vecchio FM, Greco AV, Gasbarrini G. (1998). Cholestatic hepatitis due to ticlopidine: clinical and histological recovery after drug withdrawal. Case report and review of the literature. Eur J Gastroenterol Hepatol. (72 year old woman developed jaundice 6 months after starting ticlopidine [bilirubin 4.4 mg/dL, ALT 466 U/L, Alk P 802 U/L, GGT 456 U/L], resolving in 3 months documented by second liver biopsy).
Carvajal García-Pando A, García Ortega P, Rueda de Castro AM, García del Pozo J. (1999). Med Clin (Barc). (Between 1990-98, 301 adverse reactions to ticlopidine were reported to a Spanish registry of which 47 [21%] were hepatic [2.15:10,000 person-years]; among 10 "definite" cases, latency ranged from 7-55 days and most were cholestatic, no fatalities).
Amaro P, Nunes A, Macoas F, Ministro P, Baranda J, Cipriano A, Martins I, et al. (1999). Ticlopidine-induced prolonged cholestasis: a case report. Eur J Gastroenterol Hepatol. (60 year old man developed jaundice and pruritus 3 months after starting ticlopidine [bilirubin 7.8 rising to 30 mg/dL, ALT 97 U/L, Alk P 193 to 410 U/L] with subsequent protracted course, with jaundice for 5.5 months and persistent but asymptomatic elevations in Alk P [320 U/L] and GGT [450 U/L]).
Kubin CJ, Sherman O, Hussain KB, Feinman L. (1999). Delayed-onset ticlopidine-induced cholestatic jaundice. Pharmacotherapy. (86 year old man developed rash 2 weeks after starting ticlopidine with subsequent jaundice despite promptly stopping [bilirubin 0.8 rising to 24.4 mg/dL, ALT 15 to 353 U/L, Alk P 68 to 445 U/L], resolving over following 3 months).
Torrano Larrión F. (1999). Aten Primaria. (69 year old woman developed fatigue 5 weeks after starting ticlopidine [bilirubin 0.3 mg/dL, ALT 220 U/L, Alk P 399 U/L, GGT 371 U/L], resolving within 2 weeks of stopping).
Meyer MI, Kuhn M, Bühler H, Bertschinger P. (1999). Schweiz Med Wochenschr. (82 year old man developed pruritus after 3 and jaundice after 4 weeks of ticlopidine therapy [bilirubin 7.5 mg/dL, ALT 194 U/L, Alk P 923 U/L, GGT 823 U/L], with resolution of symptoms but persistence of Alk P elevations 8 months later).
Zeolla MM, Carson JJ. (1999). Successful use of clopidogrel for cerebrovascular accident in a patient with suspected ticlopidine-induced hepatotoxicity. Ann Pharmacother. (79 year old woman developed elevations in serum enzymes 5 weeks after starting ticlopidine [bilirubin 0.3 mg/dL, ALT 1008 U/L, Alk P 648 U/L]) without jaundice or symptoms, and levels fell to near normal within 20 days of switching to clopidogrel and were completely normal 4 months later).
Remy AJ, Heran B, Galindo G, Tapie C, Khemissa F, Larrey D. (1999). Gastroenterol Clin Biol. (80 year old woman developed jaundice 2 weeks after starting ticlopidine [bilirubin 11.5 mg/dL, ALT 3 times ULN, Alk P 4 times ULN, GGT 40 times ULN], biopsy showing cholestasis and steatosis, resolving within 4 months of stopping).
Bertrand ME, Rupprecht HJ, Urban P, Gershlick AH. (2000). CLASSICS Investigators. Double-blind study of the safety of clopidogrel with and without a loading dose in combination with aspirin compared with ticlopidine in combination with aspirin after coronary stenting: the clopidogrel aspirin stent international cooperative study (CLASSICS). Circulation. (Among 1020 patients undergoing coronary artery stenting treated with aspirin and either clopidogrel or ticlopidine, side effects requiring early discontinuation were less with clopidogrel, including rash [0.7% vs 2.6%] and gastrointestinal upset [1.3% vs 2.6%]; no mention of liver injury).
Tsai MH, Tsai SL, Chen TC, Liaw YF. (2000). Ticlopidine-induced cholestatic hepatitis with anti-nuclear antibody in serum. J Formos Med Assoc. (57 year old man developed jaundice 3 weeks after starting ticlopidine [bilirubin 29.3 mg/dL, ALT 305 U/L, Alk P 480 U/L, GGT 664 U/L], resolving 6 months after stopping).
Wu MS, Chan P, Lien GS, Cheng YS, Pan S. (2000). Ticlopidine-induced severe cholestatic hepatitis. Zhonghua Yi Xue Za Zhi (Taipei). (86 year old woman developed jaundice 6 weeks after starting ticlopidine [bilirubin 15.1 mg/dL, ALT 360 U/L, Alk P 894 U/L, GGT 1641 U/L] and died suddenly 14 days later).
Berent R, Hinterholzer G, Höng W, Auer J, Haidenthaler A, Knoflach P. (2000). Z Gastroenterol. (71 year old man developed fatigue followed by pruritus and jaundice 2-3 weeks after starting ticlopidine [bilirubin 12.5 rising to 18.6 mg/dL, ALT 61 U/L, Alk P 305 U/L, GGT 143 U/L], resolving within 2 months of stopping).
Pizarro AE, Andrade RJ, García-Cortés M, Lucena MI, Pérez-Moreno JM, Puertas M, Sánchez-Martínez H, et al. (2001). Rev Neurol. (12 cases of ticlopidine hepatotoxicity reported to Spanish Pharmacovigilance Registry [5% of total reports]; 10 were men, ages 59-81 [m=68] years, 2/3rds hospitalized, latency of 2 to 13 [m=5.6] weeks, 75% cholestatic, resolving in 7 to 60 weeks, not seemingly dose related).
Placci A, Melandri G, Cecilioni L, Valgimigli M, Bolondi L, Branzi A. (2001). Ital Heart J Suppl. (65 year old man developed jaundice and pruritus 1 month after starting ticlopidine [bilirubin 11.3 mg/dL, ALT 310 U/L, Alk P 921 U/L], treated with corticosteroids and symptoms resolved rapidly while Alk P fell to normal 6 months after stopping ticlopidine).
López López M, Martín López A, Moreno Feliu R. (2001). Ticlopidina, colestasis y nódulos hepáticos. Med Clin (Barc). (52 year old man developed pruritus and jaundice 4 to 8 weeks after starting ticlopidine [bilirubin 2.3 mg/dL, ALT 408 U/L, Alk P 576 U/L], symptoms resolving in 4 weeks but enzyme elevations requiring 10 months to resolve).
Blanco JR, Márquez M, Salcedo J, Zabala M. (2001). An Med Interna. (91 year old man developed worsening fatigue 1 week after starting ticlopidine [bilirubin not given, ALT 70 rising to 129 U/L, Alk P 259 rising to 362 U/L], resolving upon stopping).
Chen LK, Hsieh BH, Chen WC, Tsai ST, Hou MC. (2001). Ticlopidine-induced hepatitis. Zhonghua Yi Xue Za Zhi (Taipei). (72 year old man developed jaundice 3 weeks after starting ticlopidine [bilirubin 12.8 mg/dL, ALT 847 U/L, Alk P 487 U/L], resolving within 10 weeks of stopping: Case 2).
García Ortega P, José Navarro J, Carvajal A, García del Pozo J. (2001). Med Clin (Barc). (52 year old man developed jaundice 2 months after starting ticlopidine [bilirubin 3.0 mg/dL, ALT 479 U/L, Alk P 415 U/L], improving on stopping but recurring on restarting ticlopidine [ALT 105 U/L, Alk P 1067 U/L], with full recovery upon stopping permanently).
Zapater P, Such J, Pérez-Mateo M, Horga JF. (2002). A new Poisson and Bayesian-based method to assign risk and causality in patients with suspected hepatic adverse drug reactions: a report of two new cases of ticlopidine-induced hepatotoxicity. Drug Saf. (Use of Bayesian analysis to assign causality using two cases of ticlopidine hepatotoxicity as examples).
Adams L, Jeffrey GP, Deboer B, Garas G. (2002). Ticlopidine-associated cholestatic hepatitis. Intern Med J. (60 year old man developed pruritus and jaundice 3 weeks after starting ticlopidine [bilirubin 20.2 rising to 24 mg/dL, ALT 42 U/L, Alk P 776 U/L, GGT 1580 U/L], resolving within 2 months of stopping).
Rivera Vaquerizo P, Solís García del Pozo J, Villanueva Hernández P. (2002). An Med Interna. (71 year old woman developed jaundice and pruritus 6 weeks after starting ticlopidine [bilirubin 16.3 mg/dL, ALT 576 U/L, Alk P 1488 U/L, GGT 2450 U/L], resolving within 2 months of stopping).
Ibáñez L, Pérez E, Vidal X, Laporte JR. (2002). Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol. (Among 107 cases of drug induced liver injury identified in a population-based survey in Spain [1993-1999], ticlopidine was the cause of 8 [7%; ranking 8th], leading to cholestatic injury in 6 and mixed injury in 2).
Skurnik YD, Tcherniak A, Edlan K, Sthoeger Z. (2003). Ticlopidine-induced cholestatic hepatitis. Ann Pharmacother. (Two cases: 66 year old man developed jaundice 6 weeks after starting ticlopidine [bilirubin 5.4 rising to 19.3 mg/dL, ALT 263 U/L, Alk P 99 U/L, eosinophils 9%], resolving in 6 months [Case 1]; 82 year old man developed jaundice 4 weeks after starting ticlopidine [bilirubin 4.0 mg/dL, ALT 440 U/L, Alk P 660 U/L, eosinophils 12%], resolving within 3 months).
Gandolfi A, Mengoli M, Rota E, Tolomelli S, Zanghieri G, Bernini MV, Lusetti L. (2004). Recenti Prog Med. (72 year old man developed jaundice and pruritus 3 weeks after starting ticlopidine [bilirubin 19.1 mg/dL, ALT 427 U/L, Alk P 1558 U/L, no eosinophilia], resolving within 6 months).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Among 103 cases of drug induced liver injury resulting in death or liver transplantation reported in Sweden between 1996-2002, ticlopidine was implicated in one).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Among 446 cases of drug induced liver injury reported to a Spanish registry over a 10-year period, 13 [13%; ranking 6th] were attributed to ticlopidine, including 7 that were hepatocellular, 5 cholestatic and 1 mixed; none fatal).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury identified between 1993 and 2000 from 12 hospitals in Barcelona, 8 were due to ticlopidine [relative risk=49.3; ranking 7th], all of which were cholestatic).
Mambelli E, Mancini E, Casanova S, Di Felice A, Santoro A. (2007). Severe ticlopidine-induced cholestatic syndrome. Blood Purif. (53 year old man with end-stage renal disease developed jaundice within 10 days of starting ticlopidine [bilirubin 16.5 rising to 40 mg/dL, ALT 162 U/L, Alk P 2356 U/L], with progressive jaundice and itching requiring liver transplantation 4 months after initial presentation; no mention of bile duct loss).
Fukushima K, Kobayashi Y, Okuno T, Nakamura Y, Sakakibara M, Nakayama T, Kuroda N, et al. (2007). Incidence of side-effects of ticlopidine after sirolimus-eluting stent implantation. Circ J. (Among 440 patients treated with ticlopidine after stent placement, 4.5% had "liver dysfunction" and 1 died of liver failure: 70 year old patient on renal dialysis with onset of jaundice 45 days after starting).
Kowalski R, Dropiński J, Brzostek T, Szot P, Rzeszutko M, Kasper M, Sawicka A, Szczeklik A. (2008). Kardiol Pol. (Abstract; 68 year old man developed jaundice after starting ticlopidine [bilirubin 5.7 mg/dL, ALT 586 U/L, Alk P 282 U/L], resolving within 6 months of stopping).
Lee JY, Park EB, Ahn JH, Suh SJ, Jung YK, Kim JH, Shin BK, et al. (2008). Korean J Hepatol. (Abstract only: patient developed pure red cell aplasia and cholestatic hepatitis while taking ticlopidine).
Hirata K, Takagi H, Yamamoto M, Matsumoto T, Nishiya T, Mori K, Shimizu S, et al. (2008). Ticlopidine-induced hepatotoxicity is associated with specific human leukocyte antigen genomic subtypes in Japanese patients: a preliminary case-control study. Pharmacogenomics J. (Analysis of HLA haplotypes in 22 Japanese patients with ticlopidine hepatotoxicity and 85 controls, found association of cholestatic liver injury with five alleles and the extended haplotype A*33:03-B*44:03-Cw*14:03-DRB1*13:02-DQB1*16:04 [71% vs 11%]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to ticlopidine or clopidogrel).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to ticlopidine or clopidogrel).
Previtera AM, Pagani R. (2010). Agranulocytosis and hepatic toxicity with ticlopidine therapy: a case report. J Med Case Rep. (70 year old woman developed agranulocytosis [neutrophils 100/µL] 4 weeks after starting ticlopidine with abnormal liver tests [bilirubin normal, ALT 560 U/L, Alk P 821 U/L, GGT 449 U/L], resolving within 4 weeks of stopping [and switching to dipyridamole and aspirin]).
Anselmino M, Moretti C, Ravera L, Sheiban I. (2010). Clopidogrel treatment in a patient with ticlopidine-induced hepatitis following percutaneous coronary stenting. Minerva Cardioangiol. (81 year old woman developed jaundice 45 days after starting ticlopidine [details not given] and recovered after stopping; one year later clopidogrel was started without recurrence of liver injury).
Petronijevic M, Ilic K, Suzuki A. (2011). Drug induced hepatotoxicity: data from the Serbian pharmacovigilance database. Pharmacoepidemiol Drug Saf. (Among 1804 adverse events reported to a Serbian pharmacovigilance registry between 1995 and 2008, 70 were hepatic of which 6% were fatal; ticlopidine accounted for 2 cases [3%] with latencies of 18 days and 5 months, one with enzyme elevations alone and one with jaundice; both recovered).
Motola D, Biagi C, Leone R, Venegoni M, Lapi F, Cutroneo P, Vargiu A, et al. (2012). Ticlopidine safety profile: a case/non-case study on the basis of the spontaneous ADRs reporting in Italy. Curr Drug Saf. (Analysis of 478 adverse event reports related to ticlopidine from 8 Italian regions from 1990 to 2007 identified 103 as liver related, including one death due to "cholestatic jaundice").
Kaniwa N, Saito Y. (2013). Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet. (Review of the associations of severe cutaneous adverse reactions with genetic markers; mentions that ticlopidine induced liver injury has been linked to A*33:03 in Japanese populations [Hirata 2008]).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to ticlopidine or clopidogrel).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to ticlopidine or clopidogrel).
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium. (2017). Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (Genome wide analysis studies done on 862 patients with drug induced liver injury found an association with a single nucleoside polymorphism linked to HLA-A*33:01 that was highly associated with five drugs [allele frequency in controls: 0.01] including ticlopidine (0.40], terbinafine [0.21], methyldopa [0.25] and fenofibrate [0.28]).
Usui T, Tailor A, Faulkner L, Meng X, Farrell J, Daly AK, Dear GJ, et al. (2018). HLA-A*33:03-restricted activation of ticlopidine-specific T-cells from human donors. Chem Res Toxicol. (T cells from 2 of 3 healthy donors with HLA-A*33:03 were activated in vitro by priming with ticlopidine, whereas none of 3 donors without this HLA allele [which is homologous to A*33:01] were activated, and the HLA-specific activation was blocked by antibody suggesting a direct immune reactivity to the drug in subjects with this HLA-type).
Gabbi C, Bertolotti M. (2020). Reduced multidrug resistance-associated protein 2 in ticlopidine-induced cholestatic liver injury. Dig Liver Dis. (86 year old woman developed jaundice 2 months after starting ticlopidine [bilirubin 5.7 mg/dL, ALT 262 U/L, Alk P 2009 U/L, liver biopsy showing cholestatic hepatitis and weak staining for MRP2], the injury resolving within 6 weeks of stopping drug).

## OTHER REFERENCE LINKS

1 Recent References on Ticlopidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ticlopidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ticlopidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ticlopidine)